# Darunavir

## OVERVIEW

### Introduction

Darunavir is an antiretroviral protease inhibitor that is used in the therapy and prevention of human immunodeficiency virus (HIV) infection and the acquired immunodeficiency syndrome (AIDS). Darunavir can cause transient and usually asymptomatic elevations in serum aminotransferase levels and has been linked to rare instances of clinically apparent, acute liver injury. In HBV or HCV coinfected patients, highly active antiretroviral therapy with darunavir may result of an exacerbation of the underlying chronic hepatitis B or C.

### Background

Darunavir (dar ue' na vir) is a proteinomimetic, azapeptide that blocks the catalytic site of the HIV protease preventing cleavage of viral polyprotein precursors into mature, functional proteins that are necessary for viral replication. When given in combination with other antiretroviral agents, darunavir has been shown to lower HIV RNA levels and delay onset of AIDS related complications. Darunavir was approved for use in the United States in 2003 and is indicated for the treatment of HIV, typically in combination with low “booster” doses of ritonavir, a potent CYP 3A4 inhibitor. Darunavir is available under the brand name Prezista in tablets of 75, 150, 400, 600 and 800 mg and as an oral suspension (100 mg/mL). The usual adult dosage is 800 mg with ritonavir (100 mg) once daily. Higher doses and twice daily administration are sometimes recommended for patients with darunavir resistance mutations. A fixed combination of darunavir (800 mg) with the CYP 3A4 inhibitor cobicistat (150 mg) was approved for use in HIV infection in 2016 under the brand name Prezcobix, the recommended dose being one tablet daily. Common side effects of darunavir are nausea, diarrhea, gastrointestinal upset, headache, fatigue, rash and, with long term use, hyperlipidemia and lipodystrophy. Severe adverse events can include hypersensitivity reactions including Stevens Johnson syndrome. The combination of darunavir with a CYP 3A4 inhibitor also predisposes to significant drug-drug interactions.

### Hepatotoxicity

Some degree of serum aminotransferase elevations occur in a high proportion of patients taking darunavir containing antiretroviral regimens. Moderate-to-severe elevations in serum aminotransferase levels (above 5 times the upper limit of normal) are found in 3% to 10% of patients overall, and rates are higher in patients with HIV-HCV coinfection. In clinical trials of darunavir elevations in serum ALT above 5 times ULN occurred in 2% to 3% of patients, but no subject developed clinically apparent liver injury with jaundice. The serum enzyme elevations during therapy are usually asymptomatic and self-limited and can resolve even with continuation of the medication. Clinically apparent acute liver injury due to darunavir has been reported since its approval and more widescale use, but none have been well characterized for clinical features. Assigning causality to a specific anti-HIV medication is often difficult because most patients are taking multiple antiviral agents and many have accompanying chronic hepatitis B or C or nonalcoholic steatohepatitis. In reported cases, the liver injury generally arises after 1 to 8 weeks of therapy and the pattern of serum enzyme elevations is usually, but not always, hepatocellular. Signs of hypersensitivity (fever, rash, eosinophilia) are rare, as is autoantibody formation. The acute liver injury is usually self-limited and resolves within a few weeks of stopping darunavir. However, fatal instances have been reported, at least to the sponsor and monitoring of liver enzymes during therapy is recommended.

Finally, initiation of darunavir based highly active antiretroviral therapy can lead to exacerbation of an underlying chronic hepatitis B or C in coinfected individuals, typically arising 2 to 12 months after starting therapy and associated with a hepatocellular pattern of serum enzyme elevations and increases in serum levels of hepatitis B virus (HBV) DNA or hepatitis C virus (HCV) RNA. Darunavir therapy has not been clearly linked to lactic acidosis and acute fatty liver that is reported in association with several nucleoside analogue reverse transcriptase inhibitors.

Likelihood score: C (probable, rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the clinical hepatotoxicity from darunavir is not clearly known. Darunavir is extensively metabolized by the liver, largely by the cytochrome P450 system (CYP3A4), and toxic intermediates may be the cause of some liver injury. In patients with HIV infection who are coinfected with either HBV or HCV, initiation of potent antiretroviral therapy may be associated with flares of the underlying chronic hepatitis, which may be the result of reconstitution of the immune system, viral interactions or a direct effect of the drug on the hepatitis virus.

### Outcome and Management

The severity of liver injury due to darunavir ranges from transient, asymptomatic serum aminotransferase elevations to acute hepatitis that can be severe and even fatal. In typical cases, recovery occurs within 1 to 2 months and neither chronic hepatitis nor vanishing bile duct syndrome have been reported. Rechallenge should be avoided. There does not appear to be cross sensitivity in the hepatic injury to other protease inhibitors or antiretroviral agents. The exacerbation of hepatitis B or C that can occur with darunavir based antiretroviral therapies can be severe and can lead to liver failure or progressive end stage liver disease. Patients with HCV or HBV coinfection should be monitored prospectively for viral and serum aminotransferase levels and appropriate therapy of the hepatitis instituted if possible.

References to darunavir are included with references to all the HIV protease inhibitors in the overview section of protease inhibitors (updated September 2017). Most of the HIV protease inhibitors in clinical use are proteinomimetic drugs and are structurally unrelated.

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Protease Inhibitors: Amprenavir, Atazanavir, Fosamprenavir, Indinavir, Lopinavir, Nelfinavir, Ritonavir, Saquinavir, Tipranavir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Darunavir – Prezista®, Prezcobix® (with Cobicistat)

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Darunavir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Darunavir | 206361-99-1 | C27-H37-N3-O7-S

## OTHER REFERENCE LINKS

Recent References on Darunavir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Darunavir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Darunavir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Darunavir)